# Aripiprazole

## OVERVIEW

### Introduction

Aripiprazole is an atypical antipsychotic used in the treatment of schizophrenia and bipolar illness. Aripiprazole therapy has not been associated consistently with serum aminotransferase elevations and has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Aripiprazole (ar" i pip' ra zole) is a partial agonist for dopamine type 2 (D2) and serotonin (5-HT1A) receptors and has antagonist activity against serotonin 5HT2A receptors. Aripiprazole is indicated for the therapy of schizophrenia and as either monotherapy or adjunctive therapy for manic and mixed episodes in bipolar disorder, irritability associated with autistic disorder, and as adjunctive treatment with antidepressants for major depressive disorder. Aripiprazole is also indicated for treatment of Tourette disorder. It was approved for use in the United States in 2002 and is widely used with more than 8 million prescriptions filled yearly. Aripiprazole is available as tablets of 2, 5, 10, 15, 20 and 30 mg generically and under the brand name Abilify. It is also available as an oral solution (1 mg/mL), as orally disintegrating tablets (10 and 15 mg) and as a solution for intramuscular injection (7.5 mg/mL). The typical initial oral dose for adults is 10 to 15 mg daily, increasing to a maximum of 30 mg daily. In addition, an extended release formulation of aripiprazole has been developed and approved for use in schizophrenia. This formulation is given in a dose of 400 mg intramuscularly once monthly and is available under the brand name Abilify Maintena. Aripiprazole is generally well tolerated, but side effects can include restlessness, sedation, tremor, extrapyramidal symptoms, dizziness, blurred vision, headache, fatigue and nausea. Weight gain is uncommon. Rare, but potentially severe adverse events include suicidal ideation and behaviors, neuroleptic malignant syndrome, cerebrovascular adverse events in the elderly with dementia, hypersensitivity reactions, and body weight gain with complications of dyslipidemia and diabetes.

### Hepatotoxicity

Liver test abnormalities have not been reported to occur in patients on long term therapy with aripiprazole, but most studies have not provided information on serum enzyme results. Despite its widescale use, aripiprazole has been implicated in only rare and isolated cases of clinically apparent liver injury in the literature. All reported cases have been hepatocellular arising after 1 to 3 months of therapy and with accelerated onset in one instance upon re-exposure. Immunoallergic and autoimmune features were not present. Most cases have been anicteric, and none were fatal or resulted in chronic injury. Aripiprazole has not been reported among agents implicated in large case series of drug induced liver injury. The product label for aripiprazole mentions that hepatitis and jaundice have been reported, but no specific details were provided. Thus, clinically apparent liver injury from aripiprazole must be very rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Aripiprazole is extensively metabolized by the liver via the P450 system, largely by CYP 3A4 and 2D6 and is susceptible to drug-drug interactions with agents that induce or inhibit these microsomal enzymes. Weight gain is less prominent with aripiprazole than other atypical antipsychotic medications and the influence of weight gain during aripiprazole therapy on serum ALT levels has not been shown.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aripiprazole – Abilify®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aripiprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aripiprazole | 129722-12-9 | C23-H27-Cl2-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Goodnick PJ, Jerry JM. (2002). Aripiprazole: profile on efficacy and safety. Expert Opin Pharmacother. (Review of efficacy and safety of aripiprazole; no mention of hepatotoxicity or ALT elevations).
(2003). Aripiprazole (Abilify) for schizophrenia. Med Lett Drugs Ther. (Brief review of efficacy and safety of aripiprazole shortly after its approval in the US; most common side effects are anxiety, headache, nausea, constipation, insomnia, dizziness and somnolence; has little effect on weight; no mention of hepatotoxicity or effect on ALT levels).
(2003). Choice of an antipsychotic. Med Lett Drugs Ther. (Unlike other second generation antipsychotics, aripiprazole is a partial dopamine agonist; it has little or no effect on weight and does not increase the QT interval; no mention of hepatic effects).
Rettenbacher MA, Baumgartner S, Eder-Ischia U, Edlinger M, Graziadei I, Hofer A, Huber R, et al. (2006). Association between antipsychotic-induced elevation of liver enzymes and weight gain: a prospective study. J Clin Psychopharmacol. (Prospective study of 67 patients started on atypical antipsychotics [only 1 on aripiprazole]; ALT elevations were more frequent in the 14 patients who gained >7% of body weight than in the 53 who did not [50% vs 19%] and mean changes in ALT, AST and GGT were greater in those who gained weight; all changes were transient, asymptomatic and not associated with bilirubin elevations).
Findling RL, Robb A, Nyilas M, Forbes RA, Jin N, Ivanova S, Marcus R, et al. (2008). A multiple-center, randomized, double-blind, placebo-controlled study of oral aripiprazole for treatment of adolescents with schizophrenia. Am J Psychiatry. (302 patients enrolled in 6 week placebo controlled trial of two doses of aripiprazole; side effects were dizziness, headache, somnolence and extrapyramidal symptoms; no mention of liver test abnormalities; weight largely stable over 6 weeks).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several antidepressants [duloxetine, sertaline, fluoxetine, amitryptilline], but none of the atypical antipsychotic agents, were implicated in causing cases of liver injury).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; not with aripiprazole, ziprasidone, carbamazepine or lamotrigine).
Kane JM, Osuntokun O, Kryzhanovskaya LA, Xu W, Stauffer VL, Watson SB, Breier A. (2009). A 28-week, randomized, double-blind study of olanzapine versus aripiprazole in the treatment of schizophrenia. J Clin Psychiatry. (Controlled trial of olanzapine [n=281] vs aripiprazole [n=285] for 28 weeks at 60 centers; no mention of ALT values; mean weight gain was 3.4 kg in olanzapine- vs 0.3 kg in aripiprazole treated subjects [p<.001]).
Glick ID, Mankoski R, Eudicone JM, Marcus RN, Tran QV, Assunção-Talbott S. (2009). The efficacy, safety, and tolerability of aripiprazole for the treatment of schizoaffective disorder: results from a pooled analysis of a sub-population of subjects from two randomized, double-blind, placebo-controlled, pivotal trials. J Affect Disord. (Pooled analysis of previous trials of aripiprazole for 4 weeks; no mention of liver test abnormalities and only minimal changes in body weight).
Janicak PG, Glick ID, Marder SR, Crandall DT, McQuade RD, Marcus RN, Eudicone JM, et al. (2009). The acute efficacy of aripiprazole across the symptom spectrum of schizophrenia: a pooled post hoc analysis from 5 short-term studies. J Clin Psychiatry. (Pooled analysis of 5 studies of aripiprazole vs placebo or haloperidol for 4-6 weeks; no mention of side effects).
Kwon JS, Jang JH, Kang DH, Yoo SY, Kim YK, Cho SJ, APLUS study group. (2009). Long-term efficacy and safety of aripiprazole in patients with schizophrenia, schizophreniform disorder, or schizoaffective disorder: 26-week prospective study. Psychiatry Clin Neurosci. (300 Korean patients were treated with aripiprazole for 8 weeks and some for up to 24 weeks; average weight gain of 2 kg; no mention of liver test abnormalities, jaundice or hepatitis).
Leucht S, Corves C, Arbter D, Engel RR, Li C, Davis JM. (2009). Second-generation versus first-generation antipsychotic drugs for schizophrenia: a meta-analysis. Lancet. (Systematic review of efficacy and safety of newer antipsychotic agents including aripiprazole; no discussion of liver related side effects or ALT elevations).
Kim SW, Shin IS, Kim JM, Bae KY, Yang SJ, Yoon JS. (2010). Effectiveness of switching from aripiprazole to ziprasidone in patients with schizophrenia. Clin Neuropharmacol. (Switching 19 patients with schizophrenia from aripiprazole to ziprasidone resulted in a decline in mean ALT levels [26 to 18 U/L] and values became normal in 2 of 3 subjects with elevations on aripiprazole).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for aripiprazole).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine but none for the atypical antipsychotics).
Mahapatra S, Belgrad JL, Adeoye MA. (2011). Psychotropic drug-related eosinophilia with systemic symptoms after acute caffeine ingestion. Pediatrics. (16 year old boy with bipolar disorder developed fever, generalized rash and lymphadenopathy while being treated with aripiprazole, fluoxetine and lithium and a day after consuming an energy boosting, caffeine-rich gum [eosinophils 15%, ALT 279 U/L, CPK 6169 U/L, bilirubin and Alk P not given], responding rapidly with stopping medications and corticosteroid therapy).
Fleischhacker WW, Sanchez R, Johnson B, Jin N, Forbes RA, McQuade R, Baker RA, et al. (2013). Long-term safety and tolerability of aripiprazole once monthly in maintenance treatment of patients with schizophrenia. Int Clin Psychopharmacol. (Trial of oral aripiprazole followed by once monthly injections of aripiprazole in 832 patients with schizophrenia, found no severe adverse events after 6 months of therapy and with conversion to once monthly therapy; no mention of ALT elevations or clinically apparent liver injury).
(2013). Long-acting injectable aripiprazole (Abilify Maintena) for schizophrenia. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of a long acting injectable formulation of aripiprazole [Abilify Maintena] for schizophrenia shortly after its approval for use in the US; does not mention hepatotoxicity or ALT elevations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, five were attributed to atypical antipsychotics [3 quetiapine, 2 olanzapine], but none to aripiprazole).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Kornischka J, Cordes J, Engelke C, Grohmann R, Agelink M. (2016). Acute drug-induced hepatitis during aripiprazole monotherapy; a case report. J Pharmacovigil. (49 year old woman with chronic schizoaffective psychosis developed jaundice 6 weeks after switching from long term clozapine to aripiprazole [bilirubin 17.9 mg/dL, ALT 2585 U/L, GGT 138 U/L], with rapid improvement and fall to near normal levels one month after stopping).
Castanheira L, Fernandes E, Levy P, Coentre R. (2019). Aripiprazole-induced hepatitis: a case report. Clin Psychopharmacol Neurosci. (28 year old woman with acute psychosis developed nausea and jaundice 21 days after starting aripiprazole [direct bilirubin 0.8, total 1.1 mg/dL, ALT 745 U/L, Alk P 224 U/L], with rapid improvement and fall to normal after stopping).
Nikogosyan G, Orias D, Goebert D, Takeshita J, Wang M. (2021). Acute aripiprazole-associated liver injury. J Clin Psychopharmacol. (49 year old woman with schizoaffective disorder, diabetes, chronic renal disease and depression developed abnormal liver tests 3 months after starting aripiprazole that improved on stopping and reappeared within 4 days of restarting [ALT rising from 123 to 479 U/L, Alk P 232 to 343 U/L, bilirubin normal, INR rising to 2.1], which improved after stopping).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%], and risperidone [27 of 51,683: 0.05%], whereas aripiprazole was rarely implicated [2 of 15,988, none as a single agent] and no cases were found among the 3568 patients receiving ziprasidone; two fatal cases occurred in olanzapine-treated patients).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Aripiprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Aripiprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Aripiprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aripiprazole)